# Trastuzumab Emtansine

## OVERVIEW

### Introduction

Trastuzumab emtansine (also known as ado-trastuzumab emtansine) is a humanized monoclonal antibody to the human epidermal growth factor receptor-2 (HER2) conjugated with a microtubule inhibitor which is used in the therapy of advanced, metastatic breast cancer. Trastuzumab emtansine has been linked to frequent serum enzyme elevations during therapy, to occasional instance of acute clinically apparent liver injury and, when given chronically, to nodular regenerative hyperplasia and noncirrhotic portal hypertension.

### Background

Trastuzumab (tras tooz’ ue mab) emtansine (em tan’ seen) is a humanized monoclonal antibody to the human epidermal growth factor receptor-2 (HER2) conjugated to emtansine (DM1), a cytotoxic microtubule inhibitor, which is used in the therapy of advanced or metastatic forms of breast cancer that express HER2. The monoclonal antibody is linked by a cleavable tetrapeptide to the microtubule inhibitor which is released intracellularly after the conjugate binds to and is taken up by HER2 expressing cancer cells. Within the cancer cell, emtansine is released by lysosomal enzymes that cleave the linker molecule. The released emtansine then binds to microtubules causing cell cycle arrest and apoptotic cell death. This conjugate was shown to induce objective responses and improve survival in patients with unresectable or metastatic breast cancer who had progressed despite previous therapies, and it was approved for this indication in the United States in 2013. The antibody conjugate is available in single use vials of 100 mg per vial or 160 mg lyophilized powder under the brand name Kadcyla. The recommended dose is 3.6 mg/kg intravenously every 3 weeks until disease progression or intolerability. The antibody conjugate has a higher rate of adverse side effects than trastuzumab alone. The common adverse events include fatigue, nausea, vomiting, diarrhea, fever, myalgias, headache, constipation, serum enzyme elevations and thrombocytopenia. Less common but potential severe adverse events include hepatotoxicity, anaphylaxis, heart failure and embryo-fetal toxicity. Trastuzumab emtansine should be prescribed and administered only by health care workers with expertise and experience in cancer chemotherapy and management of its adverse events.

### Hepatotoxicity

In large registration trials of trastuzumab emtansine for breast and other cancers, serum enzyme elevations occurred in 20% to 80% of patients and levels rose to above 5 times the upper limit of normal (ULN) in at least 5%. Some aminotransferase elevations were accompanied by serum bilirubin elevations. Subsequent to its approval and more widespread use, instances of acute liver injury including deaths from hepatic failure were reported with trastuzumab emtansine treatment, and it received a boxed warning about hepatotoxicity with recommendations for prospective monitoring of liver tests. Some cases appeared to represent acute sinusoidal obstruction syndrome and in other cases acute, direct hepatotoxic injury.

More recently, cases of noncirrhotic portal hypertension have been described in patients on long term trastuzumab emtansine. The typical presentation is with signs and symptoms of portal hypertension after months or years of therapy and usually with only modest increases in serum aminotransferase elevations and bilirubin. Strikingly, in patients who undergo liver biopsy, cirrhosis is not present, although mild-to-moderate fibrosis is present in some. This phenotype of injury is classified as noncirrhotic portal hypertension, but the underlying liver condition is usually nodular regenerative hyperplasia with elements of sinusoidal obstruction. Hepatic imaging shows a nodular and somewhat shrunken liver and prominent splenomegaly and varices. Typically, patients improve clinically once trastuzumab emtansine is dose-reduced or discontinued, although without chemotherapy the malignancy may return and progress. Another syndrome with somewhat similar clinical features associated with long term trastuzumab emtansine therapy is a disordered, nodular liver cause by shrinkage of necrotic hepatic metastases, sometimes referred to as “pseudocirrhosis.” These patients generally do not have symptoms of liver disease, and the diagnosis is made by hepatic imaging often done as a part of routine follow up of the metastatic liver disease.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during trastuzumab emtansine therapy is not known, but appears to be dose related and may be a mild direct toxicity of the infusions. The mechanism of the hepatotoxicity may be direct injury to endothelial cells and vasculature, possibly by their take up of the conjugate or the released microtubule inhibitor from other cells. Several instances of liver injury in patients taking trastuzumab emtansine have been attributed to sinusoidal obstruction syndrome, and mild forms of it may explain the frequent serum enzyme and bilirubin elevations during trastuzumab emtansine therapy. In other instances the underlying condition appears to be nodular regenerative hyperplasia, which is likely the result of acute or chronic vascular injury or both.

### Outcome and Management

The product label for trastuzumab emtansine recommends monitoring of liver enzymes before starting and before each dose. The serum aminotransferase elevations that arise during trastuzumab emtansine therapy are usually mild-to-moderate in severity, self-limited in course, and not associated with symptoms or jaundice. In some instances, however, the injury persists or is more severe. Elevations of serum aminotransferase levels above 5 times ULN should lead to dose interruption or modification, but persistent elevations, appearance of symptoms or jaundice or evidence of sinusoidal obstruction syndrome should lead to discontinuation. Fatal instances of acute hepatic injury have been described with trastuzumab emtansine therapy. The chronic liver injury from the monoclonal-cytotoxic conjugate is generally persistent although signs and symptoms usually regress with drug discontinuation and sometimes with dose reduction alone. These clinically apparent and severe hepatic reactions have been observed with trastuzumab emtansine, but not with trastuzumab deruxtecan or with the monoclonal antibody without a conjugate.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trastuzumab Emtansine – Kadcyla®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Ado-trastuzumab%20emtansine) (Trastuzumab Emtansine)

Product labeling at DailyMed, National Library of Medicine, NIH

CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trastuzumab | 180288-69-1 (https://pubchem.ncbi.nlm.nih.gov/compound/Trastuzumab) | Monoclonal Antibody | Not Available
Trastuzumab; Deruxtecan | 1826843-81-5 | Monoclonal Antibody with; Microtubular Inhibitor | SID: 381128090
Trastuzumab; Emtansine | 1018448-65-1 | Monoclonal Antibody with; Microtubular Inhibitor | SID: 135353969

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2024

Abbreviations: CT, computerized tomography; FAERS, Food and Drug Administration Adverse Event Reporting System; HER-2, human epidermal growth factor receptor 2; MR, magnetic resonance; NRH, nodular regenerative hyperplasia; TNF, tumor necrosis factor.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2013/125427Orig1s000SumR.pdf (FDA website medical review of data on safety and efficacy provided by the sponsor in support of the 2013 approval of trastuzumab emtansine as therapy of refractory metastatic HER2 positive breast cancer, mentions that ALT elevations occurred in up to 82% of patients during therapy which were above 5 times ULN in 5%, and that at least 2 instances of death from hepatic failure occurred in treated subjects).
Trastuzumab and capecitabine for metastatic breast cancer. Med Lett Drugs Ther 1998; 40 (1039): 106-8. (Concise review of the mechanism of action, efficacy, safety and cost of trastuzumab to be used alone or with paclitaxel for metastatic breast cancer; adverse events include infusion reactions, diarrhea and cardiac toxicity [when combined with an anthracycline]; no mention of ALT elevations or hepatotoxicity). 9814369
Cobleigh MA, Vogel CL, Tripathy D, Robert NJ, Scholl S, Fehrenbacher L, Wolter JM, et al. Multinational study of the efficacy and safety of humanized anti-HER2 monoclonal antibody in women who have HER2-overexpressing metastatic breast cancer that has progressed after chemotherapy for metastatic disease. J Clin Oncol 1999; 17: 2639-48. (Among 222 women with HER2 overexpressing, refractory metastatic breast cancer who were treated with trastuzumab once weekly, one developed an anaphylactoid reaction and 20 [9%] had grade 3, and 7 [3%] grade 4 hepatic adverse events [mostly ALT or Alk P elevations], usually in those with progressive disease involving the hepatobiliary system; no mention of clinically apparent liver injury with jaundice). 10561337
Smith IE. Efficacy and safety of Herceptin in women with metastatic breast cancer: results from pivotal clinical studies. Anticancer Drugs 2001; 12 Suppl 4: S3-10. (Analysis of safety data from 930 patients in clinical trials and from over 30,000 in postmarketing surveillance indicated that trastuzumab is usually well tolerated, the most common side effect being infusion reactions, mainly with the first dose, serious reactions occurring in 0.3% of patients; trastuzumab may also have cardiac toxicity). 11989525
Vogel CL, Cobleigh MA, Tripathy D, Gutheil JC, Harris LN, Fehrenbacher L, Slamon DJ, et al. Efficacy and safety of trastuzumab as a single agent in first-line treatment of HER2-overexpressing metastatic breast cancer. J Clin Oncol 2002; 20: 719-26. (Among 114 women with metastatic breast cancer treated with two doses of trastuzumab "severe laboratory abnormalities were uncommon"; no mention of ALT elevations or hepatotoxicity). 11821453
Jones RL, Smith IE. Efficacy and safety of trastuzumab. Expert Opin Drug Saf 2004; 3: 317-27. (Review of efficacy and safety of trastuzumab mentions that it is generally well tolerated, with specific discussion of infusion reactions, cardiac and pulmonary toxicity; no mention of ALT elevations or hepatotoxicity). 15268649
Capitain O, Lortholary A, Abadie-Lacourtoisie S. [Cytolytic hepatitis and esomeprazole during chemotherapy]. Presse Med 2005; 34: 1235-6. French. (41 year old woman with breast cancer developed fatigue on the fifth day of the second course of trastuzumab and paclitaxel and one day after taking one dose of esomeprazole [bilirubin normal, ALT 14 times ULN, Alk P 1.5 times ULN], resolving within 8 days and not recurring with subsequent courses of the chemotherapy). 16230965
Romond EH, Perez EA, Bryant J, Suman VJ, Geyer CE Jr, Davidson NE, Tan-Chiu E, et al. Trastuzumab plus adjuvant chemotherapy for operable HER2-positive breast cancer. N Engl J Med 2005; 353: 1673-84. (Among 3351 women with breast cancer enrolled in two controlled trials of standard chemotherapy with or without trastuzumab, with an average follow up of 2.0 years, survival and disease free survival were superior with trastuzumab; no mention of hepatotoxicity or ALT elevations). 16236738
Piccart-Gebhart MJ, Procter M, Leyland-Jones B, Goldhirsch A, Untch M, Smith I, Gianni L, et al.; Herceptin Adjuvant (HERA) Trial Study Team. Trastuzumab after adjuvant chemotherapy in HER2-positive breast cancer. N Engl J Med 2005; 353: 1659-72. (Among 5081 women with breast cancer randomized to receive trastuzumab [for 1 or 2 years] or observation, both disease free and overall survival were greater in trastuzumab treated patients; toxicity included rare cases of congestive heart failure and death, but no mention of hepatotoxicity or ALT elevations). 16236737
Smith I, Procter M, Gelber RD, Guillaume S, Feyereislova A, Dowsett M, Goldhirsch A, et al.; HERA study team. 2-year follow-up of trastuzumab after adjuvant chemotherapy in HER2-positive breast cancer: a randomised controlled trial. Lancet 2007; 369 (9555): 29-36. (Further follow up of trial of observation vs 1 or 2 years of trastuzumab in 5102 women with breast cancer receiving conventional chemotherapy found more serious and fatal adverse events in the trastuzumab treated patients, but none were attributed to liver injury). 17208639
Muñoz A, Carrera S, Ferreiro J, de Lobera AR, Mañé JM, López-Vivanco G. Reversible liver toxicity with adjuvant trastuzumab for localized breast cancer. Ann Oncol 2007; 18: 2045-6. (31 year old woman with breast cancer developed marked ALT elevations [1403 U/L] after first infusion of trastuzumab [8 mg/kg], which resolved within 4 weeks and did not recur with subsequent lower dose regimens, although minor ALT continued to occur thereafter). 18083694
Srinivasan S, Parsa V, Liu CY, Fontana JA. Trastuzumab-induced hepatotoxicity. Ann Pharmacother 2008; 42: 1497-501. (54 year old woman with breast cancer on paclitaxel and trastuzumab developed progressive increases in ALT, starting with first dose and resulting in discontinuation after 8th cycle, falling to normal thereafter). 18780811
Burris HA 3rd, Rugo HS, Vukelja SJ, Vogel CL, Borson RA, Limentani S, Tan-Chiu E, et al. Phase II study of the antibody drug conjugate trastuzumab-DM1 for the treatment of human epidermal growth factor receptor 2 (HER2)-positive breast cancer after prior HER2-directed therapy. J Clin Oncol 2011; 29: 398-405. (Among 112 patients with advanced breast cancer despite previous therapy who were treated with trastuzumab emtansine for an average of 4 months, common side effects were fatigue, nausea and headache; rates of ALT elevations were not provided, but one patient stopped therapy early because of "thrombocytopenia and hepatotoxicity"). 21172893
Verma S, Miles D, Gianni L, Krop IE, Welslau M, Baselga J, Pegram M, et al.; EMILIA Study Group. Trastuzumab emtansine for HER2-positive advanced breast cancer. N Engl J Med 2012; 367: 1783-91. (Among 991 women with HER2 expressing breast cancer who had failed previous therapy who received either trastuzumab emtansine or lapatinib with capecitabine, overall survival was improved with the antibody conjugate, but ALT levels were elevated in 17%, AST in 22%, and platelets decreased in 28% of patients; 3 patients stopped therapy early because of aminotransferase elevations, but no patient had both bilirubin and marked ALT elevations and there were no liver related deaths). 23020162
Krop IE, LoRusso P, Miller KD, Modi S, Yardley D, Rodriguez G, Guardino E, et al. A phase II study of trastuzumab emtansine in patients with human epidermal growth factor receptor 2-positive metastatic breast cancer who were previously treated with trastuzumab, lapatinib, an anthracycline, a taxane, and capecitabine. J Clin Oncol 2012; 30: 3234-41. (Among 110 patients with advanced, refractory breast cancer treated with trastuzumab emtansine for an average of 17 months, ALT elevations occurred in 14% and one patient died from "abnormal hepatic function"). 22649126
Vucicevic D, Carey EJ, Karlin NJ. Trastuzumab-induced hepatotoxicity: a case report. Breast Care (Basel) 2013; 8: 146-8. (60 year old woman was found to have serum enzyme elevations without symptoms 41 days after finishing 6 months [8 cycles] of trastuzumab and while receiving trastuzumab exemestane [bilirubin 1.0 mg/dL, ALT 91 rising to 523 U/L, Alk P 100 rising to 231 U/L, INR 0.94], resolving incompletely 4 months later). 24419371
Ado-trastuzumab emtansine (Kadcyla) for HER2-positive metastatic breast cancer. Med Lett Drugs Ther 2013; 55 (1425): 75-6. (Concise summary of mechanism of action, efficacy, safety and costs of trastuzumab emtansine, a conjugate of trastuzumab with a microtubule inhibitor, mentions that increased aminotransferase levels occurred in more than 25% of patients and serious, sometimes fatal, liver toxicity has been reported). 24662957
Force J, Saxena R, Schneider BP, Storniolo AM, Sledge GW Jr, Chalasani N, Vuppalanchi R. Nodular regenerative hyperplasia after treatment with trastuzumab emtansine. J Clin Oncol 2016; 34 (3): e9-12. (Two women, ages 66 and 50 years, with metastatic breast cancer presented with evidence of portal hypertension [ascites, varices, low platelet counts] 16 months after starting cyclic therapy with trastuzumab emtansine [bilirubin normal, ALT 48 and ~120 U/L, Alk P 400 U/L and not given], biopsy showing nodular regenerative hyperplasia and both patients improving when the agent was stopped). 24778392
Miller KD, Diéras V, Harbeck N, Andre F, Mahtani RL, Gianni L, Albain KS, et al. Phase IIa trial of trastuzumab emtansine with pertuzumab for patients with human epidermal growth factor receptor 2-positive, locally advanced, or metastatic breast cancer. J Clin Oncol 2014; 32: 1437-44. (Among 64 women with HER2 positive metastatic breast cancer [HER2 positive] treated with the combination of pertuzumab and trastuzumab emtansine [every 3 weeks], common side effects were fatigue [61%], nausea [50%] and diarrhea [39%] and "hepatic dysfunction" in 38% with ALT levels above 5 times ULN in 9%). 24733796
Ishizuna K, Ninomiya J, Ogawa T, Tsuji E. Hepatotoxicity induced by trastuzumab used for breast cancer adjuvant therapy: a case report. J Med Case Rep 2014; 8: 417. (60 year old Japanese woman with breast cancer developed liver test abnormalities after a second cycle of trastuzumab [bilirubin normal, ALT 246 U/L, Alk P 553 U/L] which recurred one year later after readministration of a single infusion [bilirubin normal, ALT 102 U/L, Alk P 377 U/L], resolving within 2 months of stopping). 25491149
Spano JP, Beuzeboc P, Coeffic D, Arnould L, Lortholary A, Andre F, Ferrero JM. Long term HER2+ metastatic breast cancer survivors treated by trastuzumab: Results from the French cohort study LHORA. Breast 2015; 24: 376-83. (Among 160 women with breast cancer treated with trastuzumab [for a median of 5.3 years], long term adverse events included cardiac failure and cardiomyopathy; no mention of ALT elevations or hepatotoxicity). 25913287
Ghabril M, Vuppalanchi R. Drug-induced nodular regenerative hyperplasia. Semin Liver Dis 2014; 34: 240-5. (Review of the clinical presentation, etiology, course and management of nodular regenerative hyperplasia which is often due to medications including trastuzumab emtansine). 24879987
Diéras V, Harbeck N, Budd GT, Greenson JK, Guardino AE, Samant M, Chernyukhin N, Smitt MC, Krop IE. Trastuzumab emtansine in human epidermal growth factor receptor 2-positive metastatic breast cancer: an integrated safety analysis. J Clin Oncol 2014; 32: 2750-7. (Among 884 patients with HER2 positive breast cancer treated with trastuzumab emtansine in 6 controlled trials, common adverse events were fatigue [46%], nausea [43%], thrombocytopenia [32%], headache [29%], constipation [27%] and ALT elevations [16%], typically during the first few months, rising to above 5 times ULN in 3.1%, resulting in drug discontinuation in 0.5% and death in 2 patients). 25024070
Mandaliya H, Baghi P, Prawira A, George MK. A rare case of paclitaxel and/or trastuzumab induced acute hepatic necrosis. Case Rep Oncol Med 2015; 2015: 825603. (62 year old woman with HER2 positive breast cancer developed acute respiratory failure within 12 hours of first dose of paclitaxel and trastuzumab, liver test results “were inconclusive” and she died 36 hours later: “surprisingly, autopsy showed acute hepatic/liver necrosis”). 26605100
Bishop AJ, Ensor J, Moulder SL, Shaitelman SF, Edson MA, Whitman GJ, Bishnoi S, et al. Prognosis for patients with metastatic breast cancer who achieve a no-evidence-of-disease status after systemic or local therapy. Cancer 2015; 121: 4324-32. (Among 570 patients with metastatic breast cancer seen between 2003 and 2005 at a single referral center, overall 5 year survival was 24%, but was higher in those who achieved “no evidence of disease” status [78% vs 13%] and those who received trastuzumab, no mention of adverse events or hepatotoxicity). 26348887
Giuliani J, Bonetti A. Acute liver failure caused by metastatic breast cancer: can we expect some results from chemotherapy? Dig Dis Sci 2015; 60: 2541-3. (35 year old woman with HER2 positive breast cancer developed evidence of metastatic replacement of the liver [bilirubin 5.0 mg/dL, ALT 236 U/L, GGT 449 U/L] and improvement with combination chemotherapy including trastuzumab, liver tests returning to normal but then died with progressive disease 9 months later, indicating that this symptom is not as grim as previously reported using more modern chemotherapeutic regimens). 26088368
Sharp A, Johnston SR. Dose-reduced trastuzumab emtansine: active and safe in acute hepatic dysfunction. Case Rep Oncol 2015; 8: 113-21. (59 year old woman with HER2 positive breast cancer, refractory after multiple chemotherapy regimens, developed jaundice associated with a 7 cm liver mass [bilirubin ~8.2 mg/dL, ALT ~1000 U/L, Alk P ~650 U/L], which responded to trastuzumab emtansine with resolution of jaundice, improvement in liver enzymes, and shrinkage of the mass). 25873876
Gelmon KA, Boyle FM, Kaufman B, Huntsman DG, Manikhas A, Di Leo A, Martin M, et al. Lapatinib or trastuzumab plus taxane therapy for human epidermal growth factor receptor 2-positive advanced breast cancer: final results of NCIC CTG MA.31. J Clin Oncol 2015; 33: 1574-83. (Among 652 patients with HER2 positive advanced breast cancer treated with lapatinib or trastuzumab combined with a taxane, progression free survival was better with trastuzumab, while symptoms of rash, diarrhea and febrile neutropenia were more common with lapatinib, decrease in left ventricular function arose in 2.3% of trastuzumab vs 0% of lapatinib recipients, and “hepatic dysfunction” occurred in <1% of both groups). 25779558
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, only four cases were attributed to a monoclonal antibody [3 to infliximab and 1 to adalimumab]; no cases were attributed to trastuzumab). 25754159
Yan H, Endo Y, Shen Y, Rotstein D, Dokmanovic M, Mohan N, Mukhopadhyay P, et al. Ado-trastuzumab emtansine targets hepatocytes via human epidermal growth factor receptor 2 to induce hepatotoxicity. Mol Cancer Ther 2016; 15: 480-90. (In cultured human and mouse hepatocytes and in mouse models, trastuzumab emtansine can cause hepatocellular injury after binding to cell surface HER2 receptors and uptake into hepatocytes). 26712117
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of literature on hepatotoxicity of newly approved agents mentions that trastuzumab can cause ALT elevations in 7-12% of patients and rarely acute hepatitis but has not been linked to reactivation of HBV, while trastuzumab emtansine causes ALT elevations in 17-22% of patients and has been linked to cases of hepatitis, acute liver failure, portal hypertension and nodular regenerative hyperplasia [NRH], but not to reactivation of HBV). 27842767
Liu Y, Li ZY, Li X, Wang JN, Huang QA, Huang Y. Liver toxicity of chemotherapy and targeted therapy for breast cancer patients with hepatitis virus infection. Breast 2017; 35: 191-195. (Among 835 patients with breast cancer receiving targeted therapy, rates of ALT elevations were slightly higher in the 52 with HBsAg [35%] and the 21 with anti-HCV [43%] than controls [28%] as were rates of chemotherapy disruption for liver test abnormalities [9.6% and 9.5% vs 5%], but no patient developed viral reactivation, although the proportion of those with HBsAg who were receiving antiviral prophylaxis was not provided). 28800545
Liu Y, Li ZY, Wang JN, Li X, Huang QA, Huang Y. Effects of hepatitis C virus infection on the safety of chemotherapy for breast cancer patients. Breast Cancer Res Treat 2017; 164: 379-83. (Among 835 patients with breast cancer receiving target therapy, rates of “hepatitis” were slightly higher in the 21 with anti-HCV in serum [23%] than in controls [14%] as were rates of chemotherapy disruption for liver test abnormalities [9.5% vs 5%], but no patient had reactivation as define by a 1 log increase in HCV RNA levels). 28447238
Hidalgo-Blanco A, Aguirresarobe-Gil de San Vicente M, Aresti S, de Miguel E, Cabriada-Nuno JL. Pseudocirrhosis in metastatic breast cancer. Gastroenterol Hepatol 2018; 41: 111-3. (39 year old woman with HER2-positive breast cancer received a 1-year course of trastuzumab at the end of which she had normal ALT levels and CT appearance of the liver, but 18 months later she presented with abnormalities of both suggestive of pseudocirrhosis). 28187872
Lepelley M, Allouchery M, Long J, Boucherle D, Ranchoup Y, Le Marc'Hadour F, Villier C, Sturm N. Nodular regenerative hyperplasia induced by trastuzumab emtansine: role of emtansine? Ann Hepatol 2018; 17: 1067-71. (48 year old woman with HER2-negative breast cancer in 2008 had recurrence in 2012 that was HER2-positive and after 12 months of trastuzumab emtansine therapy presented with mild ALT and AST elevations and MRI showing splenomegaly and dystrophic liver, a biopsy of which showed NRH, liver abnormalities improving, but cancer progressing when chemotherapy was stopped). 30600283
Talima S, Kassem H, Kassem N. Chemotherapy and targeted therapy for breast cancer patients with hepatitis C virus infection. Breast Cancer 2019; 26: 154-63. (Two of 58 Egyptian women with advanced breast cancer and chronic hepatitis C developed viral reactivation during targeted chemotherapy, one on lapatinib and one trastuzumab). 30191397
Fujii Y, Doi M, Tsukiyama N, Hattori Y, Ohya K, Shiroma N, Morio K, et al. Sinusoidal obstruction syndrome post-treatment with trastuzumab emtansine (T-DM1) in advanced breast cancer. Int Cancer Conf J 2019; 9: 18-23. (Two women with metastatic HER2-positive breast cancer developed noncirrhotic portal hypertension after 2.5 and 4.5 years of trastuzumab emtansine therapy, and liver biopsy showed sinusoidal obstruction syndrome and disordered hepatic plates in both). 31950012
Milam P, Berger M, Ramaswamy B, Reinbolt R, Wesolowski R, Kaffenberger BH. Spider telangiectases and palmar erythema as harbingers of structural liver changes in three breast cancer patients on ado-trastuzumab emtansine. J Clin Aesthet Dermatol 2019; 12: 23-6. (Three women [ages 53, 60 and 63 years] with advanced breast cancer developed cutaneous stigmata of cirrhosis after 17 to 34 cycles of trastuzumab emtansine with spider angiomata and palmar erythema, minimal ALT and AST elevations, decreased platelet counts [43,000-123,000/µL], and usually with splenomegaly and nodular liver on CT or MR imaging). 31531159
Duret-Aupy N, Lagarce L, Blouet A, Kettani S, Conte C, Bourneau-Martin D, Drablier G, et al. Liver sinusoidal obstruction syndrome associated with trastuzumab emtansine treatment for breast cancer. Therapie 2019; 74: 675-7. (87 year old woman on trastuzumab emtansine for two years developed variceal hemorrhage, ascites and edema, with normal ALT, and CT showing no evidence of cirrhosis, but liver biopsy showing sinusoidal obstruction syndrome). 31023619
Modi S, Saura C, Yamashita T, Park YH, Kim SB, Tamura K, Andre F, et al.; DESTINY-Breast01 Investigators. Trastuzumab deruxtecan in previously treated HER2-positive breast cancer. N Engl J Med. 2020;382:610-621. (Among 184 patients with unresectable or metastatic refractory HER2 positive breast cancer treated with trastuzumab deruxtecan the objective response rate was 61% and overall adverse event rate was 99.5%, most commonly with nausea, fatigue, alopecia, vomiting, constipation, decreased appetite, and 14% of patients developed interstitial lung disease, 5% a prolonged QT interval, 2.7% infusion reactions, and ALT elevations in 12% which were above 5 times ULN in 2%; no mention of clinically apparent liver injury). 31825192
Battisti NML, Rogerson F, Lee K, Shepherd S, Mohammed K, Turner N, McGrath S, et al. Safety and efficacy of T-DM1 in patients with advanced HER2-positive breast cancer The Royal Marsden experience. Cancer Treat Res Commun. 2020;24:100188. (Among 128 patients with advanced, refractory HER2-positive breast cancer who were treated with trastuzumab emtansine at a single UK referral center from 2014 to 2019, the median overall survival rate was 20.4 months and adverse events were frequent including “deranged liver function” in 69%, “liver toxicity” in 20%, resulting in dose modification in 6%, and discontinuation in 2%). 32619830
Emens LA, Esteva FJ, Beresford M, Saura C, De Laurentiis M, Kim SB, Im SA, et al. Trastuzumab emtansine plus atezolizumab versus trastuzumab emtansine plus placebo in previously treated, HER2-positive advanced breast cancer (KATE2): a phase 2, multicentre, randomised, double-blind trial. Lancet Oncol. 2020;21:1283-1295. (Among 202 patients with advance, refractory HER2-positive breast cancer treated with trastuzumab emtansine with or without atezolizumab [anti-PD-L1], the median progression free survival was similar in the two groups [8.2 vs 6.8 months], while serious adverse events were more frequent with atezolizumab [33% vs 9%] including ALT elevations above 5 times ULN [5% vs 3%]). 33002436
Garrido I, Magalhães A, Lopes J, Macedo G. Trastuzumab Emtansine-Induced Nodular Regenerative Hyperplasia: Is Dose Reduction Enough as a Preventable Measure? Dig Dis. 2022;40:787-792. (52 year old woman with HER2-positive, metastatic lung cancer was treated with trastuzumab emtansine and had an objective clinical response, but rapidly developed persistently abnormal liver tests which worsened [peak ALT 110 U/L, Alk P 474 U/L, bilirubin 1.7 mg/dL] with fall of platelet count to 74,000/mcL, with liver biopsy showing NRH, but a decrease in dose [3.6 to 1.8 mg/kg every 3 weeks] was followed by fall of liver tests and stabilization of platelet count with maintained clinical response). 35078201
Cortés J, Kim SB, Chung WP, Im SA, Park YH, Hegg R, Kim MH, et al.; DESTINY-Breast03 Trial Investigators. Trastuzumab deruxtecan versus trastuzumab emtansine for breast cancer. N Engl J Med. 2022; 386: 1143-1154. (Among 524 patients with refractory, advanced or metastatic HER2-positive breast cancer treated with trastuzumab deruxtecan or trastuzumab emtansine, progression free survival at 1 year was 76% vs 34% and adverse event rates 98% vs 87%, with deruxtecan having higher rates of neutropenia and anemia but lower rates of ALT elevations [19.5% vs 27%] which were above 5 times ULN in 1.6% vs 4.6%). 35320644
Ma P, Tian H, Shi Q, Liu R, Zhang Y, Qi X, Chen Y. High risks adverse events associated with trastuzumab emtansine and trastuzumab deruxtecan for the treatment of HER2-positive/mutated malignancies: a pharmacovigilance study based on the FAERS database. Expert Opin Drug Saf. 2023;22:685-696. (Analysis of the FDA Adverse Event Reporting System [FARES] from 2004 to 2022 identified 2113 reports for trastuzumab emtansine [Tm] and 1269 for trastuzumab deruxtecan [Td], and while liver test abnormalities were reported with both, Tm had high report rates of hepatic cirrhosis [n=35], portal hypertension [24], and nodular regenerative hyperplasia [17], while Td had none for these diagnoses). 37068935
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023:1-12. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], trastuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Trastuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trastuzumab+Emtansine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Trastuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trastuzumab%20Emtansine)